# Lavender

## OVERVIEW

### Introduction

Lavender, also called English Lavender, is an aromatic oil extracted from the flowers or leaves of the popular garden flower, Lavandula angustifolia. Extracts, oils and teas made from lavender are used for its soothing qualities as a sedative, mild analgesic and sleep medication. Lavender has not been implicated in causing serum enzyme elevations or clinically apparent liver injury.

### Background

Lavender (lav' end der) generally describes the aromatic oil extract from the flowers and leaves of lavender plants (Lavandula angustifolia, formerly L. officinalis). English lavender is a popular ornamental plant, known for is aroma, distinctive color and ease of cultivation. The extracts contain volatile oils, consisting chiefly of monoterpenes, linalool and linalyl acetate and carohyllene epoxide. Lavender has multiple biologic effects in vitro and in vivo, including antiinflammatory, antilipidemic, antimicrobial, antineoplastic, analgesic and sedative effects. In humans, lavender has been claimed to induce relaxation and sedation and has been used to treat nervousness and insomnia. It also may have analgesic effects and is used in circulatory disorders, dyspepsia and depression as well as for hair loss. Lavender oils are commonly used in aromatherapy and are found in many skin lotions, creams, soaps and cosmetics. Lavender can also be taken as an herbal tea, inhaled or applied topically. When taken orally, it is usually diluted as a tincture with alcohol. Lavender has not been approved for use in any medical condition in the United States, but it is found in hundreds of herbal creams, lotions, bath oils and aromatic inhalants. Side effects are rare, but may include headache, constipation, dyspepsia and eructation.

### Hepatotoxicity

Despite wide scale use, lavender has not been convincingly linked to instances of clinically apparent liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Other Names: English lavender, Common lavender, True lavender, Narrow-leaved lavender, lavanda.

Drug Class: Herbal and Dietary Supplements

See also Drug Class: Sedatives and Hypnotics

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lavender – Generic (OTC Products)

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/lavender)

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lavender)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Lavender | 8000-28-0 | Unspecified | No Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 15 April 2019

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbals are discussed, including comfrey, Jin Bu huan, germander, chaparral leaf, skullcap and valerian, but not lavender).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; lavender is not discussed).
English Lavender. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc., 2007: pp. 285-9. (Compilation of short monographs on herbal medications and dietary supplements).
Gyllenhaal C, Merritt SL, Peterson SD, Block KI, Gochenour T. Efficacy and safety of herbal stimulants and sedatives in sleep disorders. Sleep Med Rev 2000; 4: 229-251. (Review of herbals used for sleep disorders; mentions that no toxicity has been reported for lavender, but it may potentiate somnolence caused by other agents). 12531167
Wheatley D. Medicinal plants for insomnia: a review of their pharmacology, efficacy and tolerability. J Psychopharmacol 2005; 19: 414-21. (Review of herbals used to treat insomnia; mentions that "there would appear to be some evidence for the belief that lavender inhalations may act as an aid to sleep"). 15982998
Meolie AL, Rosen C, Kristo D, Kohrman M, Gooneratne N, Aguillard RN, Fayle R, et al.; Clinical Practice Review Committee; American Academy of Sleep Medicine. Oral nonprescription treatment for insomnia: an evaluation of products with limited evidence. J Clin Sleep Med 2005; 1: 173-87. (Systematic review of efficacy of nonprescription treatments for insomnia; lavender is not discussed). 17561634
Kasper S, Gastpar M, Muller WE, Volz HP, Moller HJ, Dienel A, Schlafke S. Efficacy and safety of silexan, a new, orally administered lavender oil preparation, in subthreshold anxiety disorder - evidence from clinical trials. Wien Med Wochenschr 2010; 160 (21-22): 547-56. (Combined analysis of 3 controlled trials of silexan [a lavender oil preparation] in 509 patients with anxiety disorders; the only adverse events occurring more frequently in silexan group were eructation and dyspepsia; no mention of ALT levels or hepatotoxicity). 21170695
Woelk H, Schläfke S. A multi-center, double-blind, randomised study of the Lavender oil preparation Silexan in comparison to Lorazepam for generalized anxiety disorder. Phytomedicine 2010; 17: 94-9. (Among 77 paatients with generalized anxiety disorder treated with lorazepam or lavender extract for 6 weeks, Hamilton Anxiety Rating scores improved to a similar degree in both groups and adverse events were largely gastrointestinal and none were severe; no mention of ALT elevations or hepatotoxicity). 19962288
Sarris J, Panossian A, Schweitzer I, Stough C, Scholey A. Herbal medicine for depression, anxiety and insomnia: a review of psychopharmacology and clinical evidence. Eur Neuropsychopharmacol 2011; 21: 841-60. (Systematic review and summary of clinical evidence of efficacy of herbals used to treat anxiety, depression and insomnia; mentions that lavender has been studied in humans, but does not rank the herbal as having evidence for efficacy in insomnia or anxiety in humans). 21601431
Drugs for insomnia. Treat Guidel Med Lett 2012; 10 (119): 57-60. (Guidelines for therapy of insomnia; mentions herbal products that are claimed to have sleep inducing effects including valerian root, kava, chamomile tea, passionflower, hops, lemon balm, lavender and skull cap, but that there is no convincing evidence for their efficacy and that the purity of commercially available, over-the-counter products is suspect). 22777275
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, no cases were attributed to lavender). 25043597
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci 2016; 17. pii: E537. (Listing of published cases of liver injury from HDS products does not list or mention lavender).27070596
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list or mention lavender). 27402097
Barić H, Đorđević V, Cerovečki I, Trkulja V. Complementary and alternative medicine treatments for generalized anxiety disorder: systematic review and meta-analysis of randomized controlled trials. Adv Ther 2018; 35: 261-88. (Systematic review of published randomized controlled trials of herbal products used to treat anxiety discusses two studies of lavender [Woelk 2010, Kasper 2010] and concludes that the efficacy of lavender extract requires confirmation; no mention of adverse events). 29508154

## OTHER REFERENCE LINKS

1. Recent References on Lavender: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Lavender/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Lavender: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lavender)